# Golimumab

## OVERVIEW

### Introduction

Golimumab is a human monoclonal antibody to tumor necrosis factor (TNF) alpha that is used in the treatment of rheumatoid arthritis and ulcerative colitis. Golimumab has been linked to a low rate of serum enzyme elevations during therapy, but has not been linked to cases of idiosyncratic, clinically apparent liver injury with jaundice. Because golimumab is a potent inhibitor of TNF alpha, it is likely to cause reactivation of chronic hepatitis B in susceptible patients.

### Background

Golimumab (goe lim’ ue mab) is a human monoclonal immunoglobulin antibody to tumor necrosis factor (TNF) alpha, a proinflammatory cytokine that plays a role in cell injury, inflammation and tissue damage in inflammatory, autoimmune diseases. Golimumab is one of several monoclonal antibody inhibitors of TNF and has been shown to be effective in decreasing inflammation and improving symptoms in autoimmune diseases, including rheumatoid arthritis and ulcerative colitis. Golimumab was approved for use in the United States for adults with rheumatoid arthritis, psoriatic arthritis and ankylosing spondylitis in 2009, and the indications were broadened to include ulcerative colitis in adults and children (weighing more than 15 kg) in 2013. Golimumab is available in liquid solution in single use, prefilled autoinjectors of 50 and 100 mg under the brand name Simponi. It is also available in solution for intravenous administration. Golimumab is typically given by subcutaneous injection and the regimen varies by indication. For inflammatory arthritidies the recommended dose is 50 mg every month. For adults with ulcerative colitis, the recommendation is for an initial dose of 200 mg, followed by 100 mg at week 2 and then 100 mg every 4 weeks. Common side effects include injection site reactions, headache, nausea, abdominal discomfort, diarrhea, skin rash and fever. Uncommon, but potentially severe adverse reactions include bone marrow suppression, severe and opportunistic infections, neurological reactions, heart failure, malignancies including lymphoma, and hypersensitivity reactions. TNF antagonists are also capable of causing immune suppression, which can result in reactivation of microbial infections including tuberculosis and hepatitis B.

### Hepatotoxicity

In prelicensure controlled trials, serum ALT elevations occurred in up to 8% of golimumab vs 1% to 3% of placebo treated subjects. The elevations were usually mild-to-moderate in severity, asymptomatic, not accompanied by jaundice and self-limited in course. ALT elevations above 5 times the upper limit of normal (ULN) occurred in 1% to 3% of golimumab and in ~1% of placebo recipients, but only rare patients had to stop therapy because of serum enzyme elevations. Importantly, since its approval in 2009, there have been no published case reports of clinically apparent, acute liver injury with symptoms or jaundice attributed to golimumab. Thus, serum aminotransferase elevations can occur with golimumab therapy, but hepatitis with jaundice must be rare.

Nevertheless, golimumab is a potent TNF inhibitor, and virtually all TNF antagonists have been linked to cases of reactivation of hepatitis B, which can be severe and lead to acute liver failure and death or need for emergency liver transplantation. More than 100 cases of clinically apparent reactivation of hepatitis B have been attributed to TNF inhibitors such as infliximab, etanercept, adalimumab and certolizumab. Reactivation typically occurs in patients who are HBsAg carriers with inactive liver disease before treatment. The usual sequence of events is appearance of rising levels of HBV DNA in serum shortly after the anti-TNF therapy is started, followed by rise in levels of HBsAg and HBeAg. Between courses, when immune reconstitution begins, serum ALT and AST levels start to rise followed by symptoms and jaundice. The onset of liver injury is usually after 3 to 6 monthly injections of the TNF antagonist. Reactivation of hepatitis B tends to be severe and the mortality rate in jaundiced cases exceeds 10%. Liver histology demonstrates an acute hepatitis-like pattern with focal or confluent necrosis and prominent lymphocytic infiltrates of activated T cells, which is compatible with an immune mediated hepatic injury. There may also be evidence of an underlying chronic hepatitis or cirrhosis. Restarting the TNF inhibitor can result in recurrence of injury, although antiviral treatment usually blocks recurrence.

Reactivation of HBV can also occur in persons who have resolved hepatitis B (anti-HBc without HBsAg in serum) with reappearance of HBsAg in serum (“reverse seroconversion”). This form of reactivation is less common than classic reactivation (in an HBsAg carrier), yet tends to be more severe. Reverse seroconversion is rare in patients on anti-TNF therapy, occurring more frequently with rituximab or more rigorous forms of immunosuppression (myeloablation and hematopoietic cell transplantation). Reverse seroconversion has yet to be described as a result of golimumab therapy.

Because of the possibility of reactivation of hepatitis B with anti-TNF therapy, screening for markers of HBV infection before starting therapy is recommended. Patients with HBsAg in serum should receive prophylaxis with oral anti-HBV therapy. Patients with anti-HBc without HBsAg in serum should be monitored for evidence of reactivation and treated promptly with antiviral therapy if HBV DNA or HBsAg appear.

Finally, golimumab may reactivate other viral infections and acute hepatitis due to an opportunistic viral infection may occur.

Likelihood score: E* (unproven but suspected cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism of liver injury in reactivation of hepatitis B appears to be a brisk immunological response to newly expressed viral antigens. Injury generally arises after anti-TNF therapy has stopped or between courses of treatment. It is not clear why liver injury occurs most commonly with infliximab and occurs less frequently with adalimumab and is evidently rare with golimumab and certolizumab.

### Outcome and Management

Guidelines for management of patients who are to receive golimumab recommend routine screening for hepatitis B before starting treatment. Screening should include tests for HBsAg and anti-HBc (and perhaps also anti-HBs as this may help in management). Prophylaxis with a potent oral, antiviral agent effective against hepatitis B is recommended for all persons who have HBsAg in serum and is suggested for those with anti-HBc without HBsAg. An alternative approach is careful monitoring for HBV DNA during therapy and prompt institution of antiviral therapy if levels rise. The antiviral agents of choice are tenofovir or entecavir. Both are given once a day and are extremely well tolerated. The appropriate duration of treatment is unclear. The typical recommendation is to continue antivirals for at least 6 months after stopping anti-TNF therapy, but cases of reactivation following withdrawal of antiviral therapy (including fatal instances) have been described and some degree of monitoring during withdrawal of antiviral therapy is perhaps appropriate.

Drug Class: Antirheumatic Agents, Tumor Necrosis Factor Antagonists; Gastrointestinal Agents, Inflammatory Bowel Disease Agents, Monoclonal Antibodies

Other Drugs in the Subclass, Tumor Necrosis Factor Antagonists: Adalimumab, Certolizumab, Etanercept, Infliximab

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Golimumab – Simponi®

DRUG CLASS

Antirheumatic Agents

Gastrointestinal Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?label=all&query=Golimumab)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Golimumab | 476181-74-5 | Monoclonal Antibody | Not Available

## ANNOTATED BIBLIOGRAPHY

References updated: 14 February 2026

Reuben A. Hepatotoxicity of immunosuppressive drugs. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2011, pp. 569-91. (Review of hepatotoxicity of immunosuppressive agents mentions that "the biological immunosuppressants are largely free from hepatotoxicity, with the exception of the TNF alpha antagonists").
MacNaughton WK, Sharkey KA. Pharmacotherapy of inflammatory bowel disease. In, Brunton LL, Hilal-Dandan R, Knollman KC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 945-54. (Textbook of pharmacology and therapeutics).
Kay J, Matteson EL, Dasgupta B, Nash P, Durez P, Hall S, Hsia EC, et al. Golimumab in patients with active rheumatoid arthritis despite treatment with methotrexate: a randomized, double-blind, placebo-controlled, dose-ranging study. Arthritis Rheum 2008; 58: 964-75. (Among 137 patients treated with methotrexate and golimumab in 4 different dose regimens compared to 34 given methotrexate alone, nausea occurred in 17% [vs 3% of controls], injection site reactions in 36% [vs 9%] and ALT elevations ≥2 times ULN in 8% [vs 3%]). 18383539
Inman RD, Davis JC Jr, Heijde Dv, Diekman L, Sieper J, Kim SI, Mack M, et al. Efficacy and safety of golimumab in patients with ankylosing spondylitis: results of a randomized, double-blind, placebo-controlled, phase III trial. Arthritis Rheum 2008; 58: 3402-12. (Among 356 patients with ankylosing spondylitis treated with golimumab or placebo for 14 weeks, transient ALT elevations occurred in 6% of golimumab and 2.6% of placebo recipients, and were ≥2 times baseline and ≥150 U/L in 3% vs 1.3%). 18975305
Emery P, Fleischmann RM, Moreland LW, Hsia EC, Strusberg I, Durez P, Nash P, et al. Golimumab, a human anti-tumor necrosis factor alpha monoclonal antibody, injected subcutaneously every four weeks in methotrexate-naive patients with active rheumatoid arthritis: twenty-four-week results of a phase III, multicenter, randomized, double-blind, placebo-controlled study of golimumab before methotrexate as first-line therapy for early-onset rheumatoid arthritis. Arthritis Rheum 2009; 60: 2272-83. (Among 637 patients with rheumatoid arthritis treated in a randomized controlled trial, responses at 24 weeks were slightly more frequent with the combination [38%] than methotrexate alone [29%] or golimumab alone [33%], but so were ALT elevations [4.4% and 6.3% vs 1.3% and 0%]). 19644849
Smolen JS, Kay J, Doyle MK, Landewé R, Matteson EL, Wollenhaupt J, Gaylis N, et al.; GO-AFTER study investigators. Golimumab in patients with active rheumatoid arthritis after treatment with tumour necrosis factor alpha inhibitors (GO-AFTER study): a multicentre, randomised, double-blind, placebo-controlled, phase III trial. Lancet 2009; 374 (9685): 210-21. (Among 461 patients with rheumatoid arthritis in a 14 week randomized controlled trial, 18% on placebo vs 35% and 38% on golimumab [50 or 100 mg monthly] had clinical improvement; no mention of ALT elevations or hepatotoxicity). 19560810
Kavanaugh A, McInnes I, Mease P, Krueger GG, Gladman D, Gomez-Reino J, Papp K, et al. Golimumab, a new human tumor necrosis factor alpha antibody, administered every four weeks as a subcutaneous injection in psoriatic arthritis: Twenty-four-week efficacy and safety results of a randomized, placebo-controlled study. Arthritis Rheum 2009; 60: 976-86. (Among 456 patients with psoriatic arthritis treated in a randomized controlled trial for 24 weeks, response rates were 48% and 51% with 50 and 100 mg of golimumab vs 9% with placebo, and rates of adverse events were similar, marked ALT elevations occurring in 0-2% of golimumab- vs 3% of placebo-recipients). 19333944
Keystone EC, Genovese MC, Klareskog L, Hsia EC, Hall ST, Miranda PC, Pazdur J, et al.; GO-FORWARD Study. Golimumab, a human antibody to tumour necrosis factor {alpha} given by monthly subcutaneous injections, in active rheumatoid arthritis despite methotrexate therapy: the GO-FORWARD Study. Ann Rheum Dis 2009; 68: 789-96. (Among 444 patients with rheumatoid arthritis in a randomized controlled trial, response rates at 14 weeks were 33% with methotrexate alone, 44% with golimumab alone and 56% with the combination, and adverse events were similar in all groups; ALT elevations were not mentioned). 19066176
Golimumab (simponi) for inflammatory arthritis. Med Lett Drugs Ther 2009; 51 (1316): 55-6. (Concise review of the mechanism of action, efficacy and safety of golimumab shortly after its approval for treatment of rheumatoid and psoriatic arthritis in the US). 19590489
Kremer J, Ritchlin C, Mendelsohn A, Baker D, Kim L, Xu Z, Han J, et al. Golimumab, a new human anti-tumor necrosis factor alpha antibody, administered intravenously in patients with active rheumatoid arthritis: Forty-eight-week efficacy and safety results of a phase III randomized, double-blind, placebo-controlled study. Arthritis Rheum 2010; 62: 917-28. (Among 444 patients treated with golimumab with or without methotrexate or placebo and methotrexate, infections were more frequent in those who received golimumab and side effects were more frequent in those who received golimumab and methotrexate; no mention of ALT elevations or hepatotoxicity). 20131276
McCluggage LK, Scholtz JM. Golimumab: a tumor necrosis factor alpha inhibitor for the treatment of rheumatoid arthritis. Ann Pharmacother 2010; 44: 135-44. (Review of the mechanism of action, pharmacology, clinical efficacy and safety of golimumab a fully humanized bivalent IgG1 monoclonal antibody to both soluble and transmembrane TNF; most common side effects are nausea and injection site reactions, serious adverse events include tuberculosis and lymphoma; no mention of ALT elevations or hepatotoxicity). 20118145
Keystone E, Genovese MC, Klareskog L, Hsia EC, Hall S, Miranda PC, Pazdur J, et al. Golimumab in patients with active rheumatoid arthritis despite methotrexate therapy: 52-week results of the GO-FORWARD study. Ann Rheum Dis 2010; 69: 1129-35. (Open label continuation of controlled trial of golimumab [Keystone 2009] showed that responses were sustained and adverse events did not increase; no mention of ALT elevations or hepatotoxicity). 20444749
Which TNF inhibitor for rheumatoid arthritis? Med Lett Drugs Ther 2010; 52 (1338): 38-9. (Discussion of the efficacy, safety and costs of the five TNF inhibitors approved for use in rheumatoid arthritis states that none have been shown to be more effective than any other and adverse effects are similar, although reactivation of tuberculosis may be less common with etanercept than infliximab). 20467356
Singh JA, Noorbaloochi S, Singh G. Golimumab for rheumatoid arthritis: a systematic review. J Rheumatol 2010; 37: 1096-104. (Systematic review of 4 controlled trials in 1231 patients treated with golimumab and 483 with placebo concluded that golimumab was more beneficial than placebo and adverse events rates were similar to those in controls; no mention of ALT elevations or hepatotoxicity). 20436075
Brunasso AM, Puntoni M, Gulia A, Massone C. Safety of anti-tumour necrosis factor agents in patients with chronic hepatitis C infection: a systematic review. Rheumatology (Oxford) 2011; 50: 1700-11. (Systematic review of 37 publications on 153 patients with hepatitis C who were treated with anti-TNF agents for an average of 12 months found only one instance of worsening during therapy and no evidence of increases in HCV RNA levels during treatment). 21690185
Smolen JS, Kay J, Landewé RB, Matteson EL, Gaylis N, Wollenhaupt J, Murphy FT, et al. Golimumab in patients with active rheumatoid arthritis who have previous experience with tumour necrosis factor inhibitors: results of a long-term extension of the randomised, double-blind, placebo-controlled GO-AFTER study through week 160. Ann Rheum Dis 2012; 71: 1671-9. (Among 459 patients with rheumatoid arthritis in a 24 week controlled trial of golimumab, 236 were continued on treatment for up to 160 weeks; listing of adverse events did not mention ALT elevations, hepatotoxicity or reactivation of hepatitis B). 22459542
Kavanaugh A, van der Heijde D, McInnes IB, Mease P, Krueger GG, Gladman DD, Gómez-Reino J, et al. Golimumab in psoriatic arthritis: one-year clinical efficacy, radiographic, and safety results from a phase III, randomized, placebo-controlled trial. Arthritis Rheum 2012; 64: 2504-17. (Open label continuation of controlled trial of golimumab for psoriatic arthritis found that clinical efficacy was maintained through 1 year and adverse events were similar to those reported earlier [Kavanaugh 2009], 3 patients discontinued therapy because of elevated ALT levels, but no new patients had "clinically meaningful" elevations in ALT since the previous report). 22378566
Aaltonen KJ, Virkki LM, Malmivaara A, Konttinen YT, Nordström DC, Blom M. Systematic review and meta-analysis of the efficacy and safety of existing TNF blocking agents in treatment of rheumatoid arthritis. PLoS One 2012; 7: e30275. (Systematic review of 26 controlled trials of anti-TNF agents for rheumatoid arthritis found similar rates of efficacy with different agents, but slightly lower rates of adverse events with etanercept, as measured by rates of discontinuation for adverse events [risk ratio=0.71]). 22272322
Braun J, Deodhar A, Inman RD, van der Heijde D, Mack M, Xu S, Hsu B. Golimumab administered subcutaneously every 4 weeks in ankylosing spondylitis: 104-week results of the GO-RAISE study. Ann Rheum Dis 2012; 71: 661-7. (Results of extended therapy with golimumab in patients enrolled in a previous controlled trial in ankylosing spondylitis [Inman 2009] found liver enzymes were more commonly elevated in those on 100 vs 50 mg of golimumab [5% vs 0.7%], no patient had concurrent elevation in ALT and bilirubin). 22012970
Emery P, Fleischmann RM, Doyle MK, Strusberg I, Durez P, Nash P, Amante E, et al. Golimumab, a human anti-tumor necrosis factor monoclonal antibody, injected subcutaneously every 4 weeks in patients with active rheumatoid arthritis who had never taken methotrexate: 1-year and 2-year clinical, radiologic, and physical function findings of a phase III, multicenter, randomized, double-blind, placebo-controlled study. Arthritis Care Res (Hoboken) 2013; 65: 1732-42. (Extended results of continuing golimumab in patients with rheumatoid arthritis enrolled in a controlled trial [Emery 2009] mentions serious adverse events of active tuberculosis in 11 patients, malignancies in 14; no mention of ALT elevations, hepatotoxicity or reactivation of hepatitis B). 23861303
Keystone EC, Genovese MC, Hall S, Miranda PC, Bae SC, Palmer W, Wu Z, et al. Golimumab in patients with active rheumatoid arthritis despite methotrexate therapy: results through 2 years of the GO-FORWARD study extension. J Rheumatol 2013; 40: 1097-103. (Further follow up on 392 patients with rheumatoid arthritis treated in a controlled trial of golimumab [Keystone 2009], who continued on either 50 or 100 mg of golimumab for 2 years mentions severe adverse events of serious infections [7%], tuberculosis [0.5%] and one patient who died of hepatic failure after "a complicated hospitalization including severe intra-abdominal hemorrhage following liver biopsy"). 23678153
Kavanaugh A, McInnes IB, Mease PJ, Krueger GG, Gladman DD, van der Heijde D, Mudivarthy S, et al. Clinical efficacy, radiographic and safety findings through 2 years of golimumab treatment in patients with active psoriatic arthritis: results from a long-term extension of the randomised, placebo-controlled GO-REVEAL study. Ann Rheum Dis 2013; 72: 1777-85. (Further follow up on 394 patients with psoriatic arthritis [Kavanaugh 2009] who were continued on golimumab [50 or 100 mg monthly] for up to 2 years, among whom 5 discontinued therapy because of raised ALT levels and 4 for raised AST levels; no mention of clinically apparent liver injury or reactivation of hepatitis B). 23161902
Kay J, Fleischmann R, Keystone E, Hsia EC, Hsu B, Mack M, Goldstein N, et al. Golimumab 3-year safety update: an analysis of pooled data from the long-term extensions of randomised, double-blind, placebo-controlled trials conducted in patients with rheumatoid arthritis, psoriatic arthritis or ankylosing spondylitis. Ann Rheum Dis 2015; 74:538-46. (Analysis of 3 year results from extension studies of 5 controlled trials of golimumab in inflammatory arthritis discusses long term adverse events of serious infections, tuberculosis, opportunistic infections, demyelination syndromes and lymphoma, but not ALT elevations, hepatotoxicity or reactivation of hepatitis B). 24344160
Sandborn WJ, Feagan BG, Marano C, Zhang H, Strauss R, Johanns J, Adedokun OJ, et al.; PURSUIT-Maintenance Study Group. Subcutaneous golimumab maintains clinical response in patients with moderate-to-severe ulcerative colitis. Gastroenterology 2014; 146: 96-109. (Among 464 patients with ulcerative colitis who achieved a clinical response during induction therapy and who were then treated with either 50 or 100 mg of golimumab or placebo, clinical responses were maintained in 47-50% of patients on golimumab vs 31% on placebo; 4 patients developed tuberculosis, 1 of whom died; no mention of ALT elevations or hepatotoxicity). 23770005
Sandborn WJ, Feagan BG, Marano C, Zhang H, Strauss R, Johanns J, Adedokun OJ, et al.; PURSUIT-SC Study Group. Subcutaneous golimumab induces clinical response and remission in patients with moderate-to-severe ulcerative colitis. Gastroenterology 2014; 146: 85-95. (Among 1064 adults with active ulcerative colitis given induction therapy, rates of response were 51-55% on golimumab vs 30% on placebo, and adverse events [through week 6] were similar; no mention of ALT elevations or hepatotoxicity). 23735746
Combe B, Dasgupta B, Louw I, Pal S, Wollenhaupt J, Zerbini CA, Beaulieu AD, et al.; GO-MORE Investigators. Efficacy and safety of golimumab as add-on therapy to disease-modifying antirheumatic drugs: results of the GO-MORE study. Ann Rheum Dis 2014; 73: 1477-86. (Among 3366 patients with rheumatoid arthritis treated with golimumab in an open label study, the most common clinically significant abnormal laboratory even was elevation in serum aminotransferase levels, but no specific rates given). 23740226
Golimumab (Simponi) for ulcerative colitis. Med Lett Drugs Ther 2014; 56 (1439): 25-6. (Concise review of the mechanism of action, efficacy, safety and costs of golimumab therapy of ulcerative colitis shortly after its approval for ulcerative colitis in the US, mentions the risk of reactivation of tuberculosis and hepatitis B with all anti-TNF agents). 24691148
Bauer H, Luxembourger C, Gottenberg JE, Fournier S, Abravanel F, Cantagrel A, Chatelus E, et al.; Club Rhumatismes et Inflammation, a section of the French Society of Rheumatology. Outcome of hepatitis E virus infection in patients with inflammatory arthritidies treated with immunosuppressants: a French retrospective multicenter study. Medicine (Baltimore) 2015; 94: e675. (Survey of French physicians treating patients with rheumatic diseases identified 23 patients who developed acute hepatitis E while being treated with immunosuppressive regimens [10 on monoclonal antibodies, 4 rituximab, 2 abatacept, 2 tocilizumab, 16 methotrexate, 4 leflunomide and 1 cyclosporine]; all recovered and cleared HEV RNA, some after reduction in immunosuppression and 5 with ribavirin therapy). 25860212
Di Bisceglie AM, Lok AS, Martin P, Terrault N, Perrillo RP, Hoofnagle JH. Recent US Food and Drug Administration warnings on hepatitis B reactivation with immune-suppressing and anticancer drugs: just the tip of the iceberg? Hepatology 2015; 61: 703-11. (Review of the pathogenesis, clinical course, treatment and prevention of HBV reactivation in patients receiving immunosuppressive or anticancer therapies, with particular focus on rituximab and ofatumumab). 25412906
Björnsson ES, Gunnarsson BI, Gröndal G, Jonasson JG, Einarsdottir R, Ludviksson BR, Gudbjörnsson B, Olafsson S. Risk of drug-induced liver injury from tumor necrosis factor antagonists. Clin Gastroenterol Hepatol 2015; 13: 602-8. (Among 11 cases of liver injury from anti-TNF agents identified over a 5 year period in Iceland, 9 were due to infliximab [among 1076 patients treated = 1:120], 1 adalimumab [of 270 treated] 1 etanercept [of 430 treated] but none for golimumab or certolizumab; 8 women, 3 men; latency 1 to 6 months; 5 were jaundiced [peak bilirubin 0.6-7.6 mg/dL, ALT 169-1658 U/L, Alk P 71-916 U/L], 8 hepatocellular, 2 cholestatic and 1 mixed injury; 8 had ANA, 5 were treated with corticosteroids [only 1 long term], 8 were switched to another TNF antagonist without recurrence). 25131534
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 6 cases [0.7%] were attributed to a tumor necrosis factor antagonist, including 3 to infliximab, 2 etanercept and 1 adalimumab, but none to certolizumab or golimumab). 25754159
Kok B, Lester ELW, Lee WM, Hanje AJ, Stravitz RT, Girgis S, Patel V, et al; United States Acute Liver Failure Study Group. Acute liver failure from tumor necrosis factor-α antagonists: report of four cases and literature review. Dig Dis Sci. 2018;63:1654-1666. (Among more than 2500 cases of acute liver failure enrolled in a prospective US database between 1998 and 2014, 4 were attributed to infliximab induced liver injury, but none were attributed to adalimumab or other TNF antagonists). 29564668
Drugs for psoriatic arthritis. Med Lett Drugs Ther. 2019;61(1588):203-210. (Concise review of the mechanism of action, efficacy, safety, and costs of drugs for psoriatic arthritis, mentions that five TNF antagonists are approved for this condition and appear to have similar efficacy and their adverse events include reactivation of hepatitis B; does not mention the risk of hepatotoxicity). 31999665
Drugs for rheumatoid arthritis. Med Lett Drugs Ther. 2021;63(1637):177-184. (Concise review of the mechanism of action, efficacy, safety, and costs of drugs for rheumatoid arthritis, mentions that five TNF antagonists are indicated for rheumatoid arthritis if maximal tolerated doses of methotrexate are not adequately effective; description of adverse events mentions reactivation of hepatitis B and induction of autoimmune conditions but not hepatotoxicity). 35085210
Akyol L, Balcı MA. Influence of anti-TNF-α treatment on liver and kidney functions in patients with ankylosing spondylitis: a retrospective longitudinal study. Eur J Rheumatol. 2022;9:31-35. (Among 148 patients with ankylosing spondylitis treated with TNF antagonists [golimumab 68, certolizumab 33, etanercept 23, adalimumab 18 and infliximab 1] for at least one year, mean ALT and AST levels remained within the normal range). 34101575
Yu J, Park SJ, Kim HW, Lim YJ, Park J, Cha JM, Ye BD, et al. Effectiveness and safety of golimumab in patients with ulcerative colitis: a multicenter, prospective, postmarketing surveillance study. Gut Liver. 2022;16:764-774. (Among 130 patients with ulcerative colitis treated with golimumab followed at 46 Korean medical centers between 2014 and 2019, 84% who tolerated therapy had a clinical response to therapy while 21% had adverse events, none of which were hepatic). 34959224
Björnsson HK, Gudbjornsson B, Björnsson ES. Infliximab-induced liver injury: clinical phenotypes, autoimmunity and the role of corticosteroid treatment. J Hepatol. 2022;76:86-92. (Among 36 Icelandic patients who developed elevated enzymes after starting infliximab therapy between 2009 and 2020, median age was 46 years, 78% were women, only 4 with jaundice, 2 hospitalized, 67% with ANA [half were positive before therapy], infliximab stopped in all but ALT elevations frequently persisted, 17 [47%] were treated with corticosteroids which led to rapid resolution [45 vs 79 days without corticosteroids], and all eventually stopped corticosteroid without relapse even when treated with other TNF antagonists). 34487751
Núñez F P, Quera R, Bay C, Castro F, Mezzano G. Drug-induced liver injury used in the treatment of inflammatory bowel disease. J Crohns Colitis. 2022;16:1168-1176. (Review of the hepatic adverse events that occur with therapies of inflammatory bowel disease such as sulfasalazine, thiopurines, methotrexate, TNF antagonists, newer monoclonal and small molecule inhibitors, and sphingosine-1-phosphate modulators). 35044449
Akyol L, Balcı MA. Influence of anti-TNF-α treatment on liver and kidney functions in patients with ankylosing spondylitis: a retrospective longitudinal study. Eur J Rheumatol. 2022;9:31-35. (Among 148 patients with ankylosing spondylitis treated with TNF antagonists [golimumab 68, certolizumab 33, etanercept 23, adalimumab 18 and infliximab 1] for at least one year, mean ALT and AST levels remained within the normal range). 34101575
Björnsson ES, Stephens C, Atallah E, Robles-Diaz M, Alvarez-Alvarez I, Gerbes A, Weber S, et al. A new framework for advancing in drug-induced liver injury research. The Prospective European DILI Registry. Liver Int. 2023;43:115-126. (Initial results from the prospective European multi-national drug-induced liver injury registry [UK, Spain, Germany, Switzerland, Portugal, Iceland] describes 246 cases, the most frequent implicated agents being amoxicillin-clavulanate [12%], flucloxacillin [11%] atorvastatin [8%], nivolumab/ipilimumab [8%], infliximab [5%], nitrofurantoin [4.5%], disulfiram [2%], ibuprofen [2%], and HDS products [7.3%]; adalimumab and other TNF antagonists not mentioned). 35899490
Drugs for inflammatory bowel disease. Med Lett Drugs Ther. 2023;65(1680):105-112. (Concise review of the mechanism of action, efficacy, safety, and costs of drugs for ulcerative colitis and Crohn disease, mentions that the monoclonal antibodies to TNF are effective in induction and maintenance of remissions, infliximab and adalimumab being approved for both forms, certolizumab for ulcerative colitis only and golimumab for Crohn disease only; discussion of adverse events mentions reactivation of hepatitis B and induction of autoimmune conditions but without mention of hepatotoxicity). 37418329
Drugs for plaque psoriasis. Med Lett Drugs Ther. 2024;66(1712):153-160. (Concise review of the mechanism of action, efficacy, safety, and costs of drugs for psoriasis, mentions that four TNF antagonists are approved for moderate-to-severe plaque psoriasis and that adverse events include reactivation of hepatitis B but does not mention hepatotoxicity). 39302348
Björnsson HK, Sigmundsson HK, Björnsson ES. Severe liver injury due to infliximab therapy and adalimumab. Scand J Gastroenterol. 2025;60:1238-1246. (Review of the literature on cases of severe liver injury attributed to TNF antagonists identified 12 reports of severe acute liver injury due to infliximab but only one due to adalimumab [Hagel 2011] and none due to golimumab or certolizumab pegol). 41086316
Bessone F, Hernandez N, Medina-Caliz I, García-Cortés M, Schinoni MI, Mendizabal M, Chiodi D, et al. Drug-induced liver injury in Latin America: 10-year experience of the Latin American DILI (LATINDILI) Network. Clin Gastroenterol Hepatol. 2025;23:89-102.. (Among 483 cases of drug-induced liver injury enrolled in a prospective Latin American database, the mostly commonly implicated agents were amoxicillin-clavulanate [n=58,14%], anti-tuberculosis drugs [n=27, 7%], nitrofurantoin [n=20, 5%], but only one case was attributed to infliximab and none to other TNF antagonists such as etanercept, adalimumab, certolizumab, and golimumab). 38992407
Kuo MH, Tseng CW, Tseng KC, Lu MC, Tung CH, Chen NT, Huang KY, et al. The relationship between TNF-α inhibitor potency and HBV reactivation in patients with rheumatic disorders. Liver Int. 2025;45:e70152.. (Among 72 HBsAg positive patients treated with TNF antagonists without prophylaxis, 21 [29%] developed reactivation vs 2 of 39 [5%] with prophylaxis, and 28 of 600 [5%] with anti-HBc without HBsAg and without prophylaxis, reactivation being more frequent with adalimumab that with etanercept or golimumab). 40418092
Chen H, Jiang S, Wang J, Zhang A, Zhu L. Hepatobiliary disorders associated with TNF-α inhibitors: a pharmacovigilance analysis of FAERS and JADER. Front Immunol. 2026;16:1739631. (Analysis of the US FDA adverse event reporting system [FAERS] between 2004 and 2025 for TNF antagonists found 19,083 reports of hepatobiliary events, 9501 for adalimumab, 3979 infliximab, 3949 etanercept, 1012 certolizumab pegol, and 642 golimumab; details on the type and severity of the hepatic adverse events were not provided). 41601665

## OTHER REFERENCE LINKS

1. Recent References on Golimumab: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Golimumab+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

2. Trials on Golimumab: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Golimumab)